# Halothane

## OVERVIEW

### Introduction

Halothane is a potent volatile halogenated anesthetic gas that has been linked to many cases of idiosyncratic acute liver injury that are frequently severe. The potential of halothane to cause hepatotoxicity and the greater safety of newer anesthetics has led to a decrease in its use, currently limited to special situations, particularly in children. Because halothane is relatively inexpensive it continues to be used in developing countries.

### Background

Halothane (hal' oh thane) is a volatile anesthetic that was used widely in major surgery between its introduction in 1956 and falling out of favor in the mid 1990s. It is nonflammable, potent and well tolerated. Halothane is administered to produce end tidal concentrations of 0.7% to 1%. It has a somewhat slow onset of action and, therefore, like other halogenated inhalational anesthetics, it is used to maintain anesthesia after induction with other agents. Halothane is no longer available in the United States, but is still used in developing countries, particularly in pediatric patients. Halothane must be administered in a controlled situation by a properly trained and credentialed anesthesiologist or nurse anesthetist and is typically given in concentrations up to 1% with oxygen.

### Hepatotoxicity

Prospective, serial blood testing often demonstrates minor transient elevations in serum aminotransferase levels in the 1 to 2 weeks after major surgery and anesthesia with halothane and other halogenated anesthetics. Appearance of ALT levels above 10 times the upper limit of normal, however, is uncommon and points to significant hepatotoxicity. Clinically apparent, severe hepatic injury from halothane is rare, occurring in ~1/15,000 cases after initial exposure, but in ~1/1,000 cases after repeated exposures. The injury is marked by acute elevations in serum aminotransferase levels (5- to 50-fold) and appearance of jaundice within 2 to 14 days of surgery. There are usually minimal increases in alkaline phosphatase levels. Fever occurs before onset of jaundice in a high proportion of patients and eosinophilia in up to 30%. Rash and arthralgias can also accompany the onset of hepatic injury. The acute liver injury may be self-limited and resolve within 4 to 8 weeks, but can be severe and lead to acute liver failure. A strong risk factor is previous exposure to any of the halogenated anesthetics and particularly a history of halothane hepatitis or unexplained fever and rash after anesthesia with one of these agents. Other risk factors are hypotension, older age, obesity and concurrent use of CYP 2E1 inducers. The differential diagnosis of acute liver injury after surgery and anesthesia is sometimes difficult, and a clinical picture similar to halothane hepatitis can be caused by shock or ischemia, sepsis, other idiosyncratic forms of drug induced liver injury and acute viral or herpes hepatitis. Indeed, many cases of severe liver injury arising soon after surgery and attributed to halothane or other halogenated anesthetics in the literature probably represent liver injury from shock and ischemia. Factors favoring the diagnosis of ischemic hepatitis are rapid onset after surgery, extremely high values for ALT, AST and LDH, and subsequent rapid fall in serum enzymes.

Likelihood score: A (well known cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of halothane hepatotoxicity is suspected to be immunoallergic, caused by creation of reactive intermediates of the anesthetic. Approximately 60% to 80% of halothane is eliminated unchanged by the lungs, but a proportion is biotransformed by hepatic microsomal enzyme CYP 2E1 to a trifluoroacetic acid which can be detected in the urine, but which also can trifluoroacetylate hepatic proteins, some of which may be immunogenic and induce cytotoxic reactions. The clinical pattern of injury is suggestive of an allergic hepatitis with rapid onset of injury, fever, eosinophilia and accelerated and more severe injury with reexposure. Patients with halothane hepatitis often have antibodies to trifluoroacetylated proteins. On the other hand, the clinical and histological pattern of halothane hepatic injury also resembles chloroform induced liver damage with centrolobular somewhat bland necrosis, suggesting that toxic intermediates of reductive halothane metabolism may cause the injury by direct injury.

### Outcome and Management

Severity ranges from mild and transient aminotransferase elevations without symptoms or other evidence of liver injury, to a self limited symptomatic acute hepatitis-like reaction, to a severe, acute hepatic failure. The severity and prognosis may relate in part of patient age, being more severe in the elderly and both milder and less common in children. Obesity may also be both a predisposing factor and predictor of outcome. Chronic liver injury from repeated halothane exposure has been described in health care workers repeatedly exposed to the agent, but the injury does not appear to lead to a chronic hepatitis if the exposure is terminated. Patients with halothane induced hepatitis should be cautioned against future exposure to a fluorinated hydrocarbon anesthetic such as isoflurane, enflurane, desflurane or sevoflurane.

Drug Class: Halogenated Anesthetics

Other Drugs in the Class: Desflurane, Enflurane, Isoflurane, Sevoflurane

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Halothane – Generic, Fluothane®

DRUG CLASS

Anesthetics, Halogenated

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=halothane)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Halothane | 151-67-7 | C2-H-Br-Cl-F3 | Halothane chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 01 January 2018

Zimmerman HJ. Anesthetic agents. In, Zimmerman HJ. Hepatotoxicity: The adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott Williams & Wilkins, 1999, pp. 457-82. (Review of hepatotoxicity from halothane and other volatile anesthetic agents published in 1999; provides a history of the controversy surrounding halothane hepatotoxicity, along with its biochemical and clinical characteristics, risk factors, histology, and suspected mechanisms).
Liver disease due to anaesthetic agents. In, Farrell GC. Drug-induced liver disease. Edinburgh: Churchill Livingstone, 1994, pp. 389-412. (Review of the history of halothane hepatitis with overview of the clinical features and pathogenesis).
Kenna JG. Mechanism, pathology, and clinical presentation of hepatotoxicity of anesthetic agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 403-22. (Review of hepatotoxicity of halothane and other halogenated anesthetic agents focusing on pathogenesis).
Patel PM, Patel HH, Roth DM. General anesthetics and therapeutic gases. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 527-64. (Textbook of pharmacology and therapeutics).
Brody GL, Sweet RB. Halothane anesthesia as a possible cause of massive hepatic necrosis. Anesthesiology 1963; 24: 29-37. (Early description of 4 cases of severe liver injury after halothane: 3 women and one man, ages 51-74 years, latency ~12 days to symptoms, 15 days to jaundice, death by 20 days, autopsy showing centrolobular massive necrosis). 14015698
Lindenbaum J, Leifer E. Hepatic necrosis associated with halothane anesthesia. N Engl J Med 1963; 268: 525-30. (Early, classic clinical description of 8 cases of halothane and one of methoxyflurane hepatitis: fever and then jaundice, typical hepatocellular enzyme pattern, slow to resolve). 13930795
Slater EM, Gibson JM, Dykes MH, Walzer SG. Postoperative hepatic necrosis. Its incidence and diagnostic value in association with the administration of halothane. N Engl J Med 1964; 270: 983-7. (Among 14,685 procedures done at one institution under halothane anesthesia over a 3 year period, authors found only one case of severe acute hepatic necrosis suggestive of halothane hepatitis). 14122794
Summary of the National Halothane Study. Possible association between halothane anesthesia and postoperative hepatic necrosis. JAMA 1966; 197: 775-88. (Analysis of all necropsies showing massive hepatic necrosis after anesthesia from 34 institutions from 1959-62 found most cases were explained by ischemia, sepsis or other conditions; among 82 cases, only 9 were considered “unexplained”, 7 followed halothane; Committee recommended further study rather than limitation of halothane use). 5953371
Klein NC, Jeffries GH. Hepatotoxicity after methoxyflurane administration. JAMA 1966; 197: 1037-9. (58 year old woman developed fever followed by jaundice on day 7 after methoxyflurane anesthesia [bilirubin 4.4 mg/dL, ALT 2000 U/L, Alk P 3.5 time ULN, 28% eosinophils], resolving within one month). 5953207
Babior BM, Davidson CS. Postoperative massive liver necrosis. A clinical and pathological study. N Engl J Med 1967; 276: 645-52. (Separate pathological review of cases of National Halothane Study; 71 cases with massive necrosis fell into two clinical and histological patterns: 56 vascular [mild or no jaundice, rapid onset, history of heart disease or shock] vs 15 hepatic [usually jaundiced, 3-20 day latency, rapid demise, no shock, architectural disturbance on biopsy]). 6018455
Gall EA. Report of the pathology panel. National Halothane Study. Anesthesiology 1968; 29: 233-48. (Report of 10,171 autopsies and 197 cases of severe hepatic necrosis; only 19 cases were unexplained, but they had no characteristic histologic pattern different from explained cases). 5639587
Klatskin G, Kimberg DV. Recurrent hepatitis attributable to halothane sensitization in an anesthetist. N Engl J Med 1969; 280: 515-22. (Famous paper on an anesthesiologist who appeared to suffer multiple relapses of liver disease due to halothane exposure: careful rechallenge was followed with ALT rising from normal to 400 U/L in one day; report predated tests for hepatitis B and C, but liver histology resembled chronic hepatitis C). 5764450
Klion FM, Schaffner F, Popper H. Hepatitis after exposure to halothane. Ann Intern Med 1969; 71: 467-77. (Analysis of 42 cases of halothane jaundice: 67% fatal; 72% previously exposed; 88% had fever, 95% jaundiced: onset jaundice in 2-15 days, ALT usually >5 times and Alk P <4 times ULN. Histology showed acute hepatitis with focal or submassive necrosis, occasionally steatosis). 5809678
Peters RL, Edmondson HA, Reynolds TB, Meister JC, Curpey TJ. Hepatic necrosis associated with halothane anesthesia. Am J Med 1969; 47: 748-64. (Analysis of 33 fatal and 8 nonfatal cases of suspected halothane hepatitis referred to pathologists at USC, found obesity and previous exposure to halothane within previous month to be risk factors, clinical pattern of fever several days before jaundice; histology separated into three stages: early, intermediate and late: necrotic, resorptive, and regenerative). 5352203
Hughes M, Powell LW. Recurrent hepatitis in patients receiving multiple halothane anesthetics for radium treatment of carcinoma of the cervix uteri. Gastroenterology 1970; 58: 790-7. (Six dramatic cases of halothane hepatitis in patients receiving multiple exposures in a protocol of repeated cervical radium implants [2-4] over a short period of time, often with an earlier episode of fever, fatal in 2 cases: no further cases occurred once halothane use was stopped). 5423891
Carney FM, Van Dyke RA. Halothane hepatitis: a critical review. Anesth Analg 1972; 51: 135-60. (Review of differential diagnosis of liver disease after surgery and anesthesia concluded that “halothane hepatitis is a real but rare entity”). 4399967
Paull A, Grant AK. Halothane hepatitis--a report of five cases. Med J Aust 1974; 1: 954-7. (Five cases of halothane hepatitis from Australia, latency of 5 to 12 days often preceded by fever occurring after 2 to 4 exposures; 1 fatal, 2 had eosinophilia, AST 100-2800 U/L, bilirubin 3.8-34 mg/L, biopsies showed hepatitis with variable amounts of necrosis, focal to submassive). 4852220
Moult PJ, Sherlock S. Halothane-related hepatitis. A clinical study of twenty-six cases. Q J Med 1975; 44: 99-114. (Classic review of halothane hepatitis; 26 patients, 25 adults, 69% women, often obese, 92% previously exposed, symptom onset in 1-12 days, jaundice rapidly following, AST markedly elevated, Alk P minimally increased, bilirubin 3.2-41.2 mg/dL; 42% fatal, no chronicity; striking demonstration of fever with previous exposures and acceleration of latency). 1153692
Wright R, Eade OE, Chisholm M, Hawksley M, Lloyd B, Moles TM, Edwards JC, Gardner MJl. Controlled prospective study of the effect on liver function of multiple exposures to halothane. Lancet 1975; 1: 817-20. (Prospective study randomizing to halothane anesthesia or not and following AST at regular intervals found elevations in 15 halothane exposed and 4 control patients; peak AST levels 40-440 U/L ~7 days, all self limiting and asymptomatic; one case had recurrence on reexposure). 48053
Hoft RH, Bunker JP, Goodman HI, Gregory PB. Halothane hepatitis in three pairs of closely related women. N Engl J Med 1981; 304: 1023-4. (3 pairs of cases of halothane hepatitis in close relatives: mother-daughter, sisters, first cousins; all Mexican, onset 2-10 days after anesthesia with fever [5/6], eosinophilia [3/6], half of which were fatal [3/6], somewhat vague in details). 7207555
Neuberger J, Mieli-Vergani G, Tredger JM, Davis M, Williams R. Oxidative metabolism of halothane in the production of altered hepatocyte membrane antigens in acute halothane-induced hepatic necrosis. Gut 1981; 22: 669-72. (Serum from halothane hepatitis cases was cytotoxic to hepatocytes from rabbits given halothane, but only if animals were exposed to high concentrations of oxygen suggesting that oxidative metabolic pathway was involved). 7286784
Døssing M, Andreasen PB. Drug-induced liver disease in Denmark. An analysis of 572 cases of hepatotoxicity reported to the Danish Board of Adverse Reactions to Drugs. Scand J Gastroenterol 1982; 17: 205-11. (Analysis of 572 cases of drug induced liver disease reported to the Danish Board on Adverse Reactions to Drugs between 1968-78 revealed halothane to be the most commonly incriminated agent in causing liver injury, 143 cases [25% of total number]). 6982502
Benjamin SB, Goodman ZD, Ishak KG, Zimmerman HJ, Irey NS. The morphologic spectrum of halothane-induced hepatic injury: analysis of 77 cases. Hepatology 1985; 5: 1163-71. (77 cases of halothane hepatotoxicity from files of Armed Forces Institute of Pathology; mean age was 50 years, 62% women, 46% obese, 73% previously exposed, symptoms arising 1-13 days after anesthesia, marked ALT elevations, 56% fatal; careful depiction of histology marked by centrolobular submassive or spotty necrosis and portal inflammation with eosinophils and neutrophils). 4065822
Pohl LR, Kenna JG, Satoh H, Christ D, Martin JL. Neoantigens associated with halothane hepatitis. Drug Metab Rev 1989; 20: 203-17. (Review of work on pathogenesis of halothane hepatitis, characterizing neoantigens covalently modified by tifluoroacetate [TFA] under aerobic conditions; also found after isoflurane and enflurane exposure). 2680380
Martin JL, Kenna JG, Pohl LR. Antibody assays for the detection of patients sensitized to halothane. Anesth Analg 1990; 70: 154-9. (ELISA assays for anti-TFA using rat serum albumin had a high false positive rate and poor sensitivity compared to ELISAs and immunoblotting using purified TFA microsomal proteins as test antigens). 2301746
Friis H, Andreasen PB. Drug-induced hepatic injury: an analysis of 1100 cases reported to the Danish Committee on Adverse Drug Reactions between 1978 and 1987. J Intern Med 1992; 232: 133-8. (In late 1980s, halothane was still the most common cause of drug induced liver injury in Denmark, but decreasing in frequency). 1506809
Martin JL, Reed GF, Pohl LR. Association of anti-58 kDa endoplasmic reticulum antibodies with halothane hepatitis. Biochem Pharmacol 1993; 46: 1247-50. (Patients with halothane hepatitis develop antibody to a 58 kDa endoplasmic reticulum [ER] protein that becomes trifluoroacetylated with halothane exposure). 8216376
Bourdi M, Chen W, Peter RM, Martin JL, Buters JTM, Nelson SD, Pohl LR. Human cytochrome P450 2E1 is a major autoantigen associated with halothane hepatitis. Chem Res Toxicol 1996; 9: 1159-66. (Anti-CYP 2E1 found in serum of 25 of 56 patients with halothane hepatitis; antibody inhibited the enzyme and was directed at conformational epitopes). 8902272
Eliasson E, Kenna JG. Cytochrome P450 2E1 is a cell surface autoantigen in halothane hepatitis. Mol Pharmacol 1996; 50: 573-82. (Rats treated with halothane developed trifluoroacetylated CYP2E1 in liver; and same protein is recognized by antibody present in 14 of 20 patients with halothane hepatitis, rarely in controls; TFA protein possibly present on hepatocyte membranes). 8794896
Pillans PI. Drug associated hepatic reactions in New Zealand: 21 years experience. N Z Med J 1996; 109: 315-9. (Spontaneous reporting of 943 cases of drug induced liver injury from 1974-94 in New Zealand implicated 205 different drugs; halothane ranked #2 [n=64] overall, but there was a decrease in frequency over the 21 years, ranking #7 from 1988-94). 8816722
Njoku DB, Greenberg RS, Bourdi M, Borkowf CB, Dake EM, Martin JL, Pohl LR. Autoantibodies associated with volatile anesthetic hepatitis found in the sera of a large cohort of pediatric anesthesiologists. Anesth Analg 2002; 94: 243-9, table of contents. (Anti-CYP 2E1 found in anesthesiologists exposed to halothane; no apparent adverse effects). 11812677
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants done in the United States between 1990 and 2002, 137 [0.2%] were done for idiosyncratic drug induced acute liver failure, of which 3 were attributed to halothane and 1 to isoflurane, but none to other halogenated anesthetics). 15390328
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-101. (36 years of reporting to Swedish registry identified 103 cases of acute liver failure due to drugs, of which 16 were attributed to halothane [ranking #1], but none to other halogenated anesthetics). 16165719
Andrade RJ, Lucena MI, Fernández MC, Pelaez G, Pachkoria K, García-Ruiz E, García-Muñoz B, et al.; Spanish Group for the Study of Drug-Induced Liver Disease. Drug-induced liver injury: an analysis of 461 incidences submitted to the Spanish registry over a 10-year period. Gastroenterology 2005; 129: 512-21. (Among 446 cases of drug induced liver disease reported in Spain between 1984-2004, neither halothane nor other anesthetic agents were listed among the major drugs implicated). 16083708
Martin JL. [Volatile anesthetics and liver injury: a clinical update or what every anesthesiologist should know.] Can J Anaesth 2005; 52: 125-9. English, French. (Brief review of clinical features and pathogenesis of anesthetic induced liver injury). 15684249
Kumar GP, Bhat VJ, Sowdi V. Fulminant hepatic failure following halothane anaesthesia. J Clin Forensic Med 2005; 12: 271-3. (38 year old man from Mangalore India underwent 6 operations with halothane anesthesia over 18 days for traumatic wounds and developed jaundice 3 days after last operation and died 5 days later with massive necrosis on autopsy). 16085447
Björnsson E, Olsson R. Suspected drug-induced liver fatalities reported to the WHO database. Dig Liver Dis 2006; 38: 33-8. (Among 4690 reports of fatal drug induced liver injury reported to the WHO database between 1968-2003, halothane ranked #5 with ~85 cases, but ~90% were reported before 1990). 16054882
Njoku DB, Mellerson JL, Talor MV, Kerr DR, Faraday NR, Outschoorn I, Rose NR. Role of CYP2E1 immunoglobulin G4 subclass antibodies and complement in pathogenesis of idiosyncratic drug-induced hepatitis. Clin Vaccine Immunol 2006; 13: 258-65. (Patients with anesthetic induced hepatitis had higher levels of antibodies to CYP 2E1 TFA adducts than controls; IgG4 specific anti-CYP2E1 was more common in cases than controls). 16467335
Qureshi MA, Saeed F, Hussain T. Halothane induced fulminant hepatic failure. J Coll Physicians Surg Pak 2007; 17: 103-4. (A 22 year old Pakistani man developed jaundice 2 days after halothane anesthesia [bilirubin 8.1 rising to 21.3 mg/dL, ALT 645 to 3208 U/L, Alk P 371 to 474 U/L], dying by postoperative day 6).17288858
Eghtesadi-Araghi P, Sohrabpour A, Vahedi H, Saberi-Firoozi M. Halothane hepatitis in Iran: a review of 59 cases. World J Gastroenterol. 2008; 14: 5322-6. (59 cases of halothane hepatitis seen at 7 hospitals in Iran between 1994 and 2006; mean age 44 years, mean time to onset 15 days, 81% women, 22% obese, 61% previous exposure, 6 deaths [12%]). 18785286
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease collected in the US between 2003 and 2008, 2 cases were attributed to desflurane, 1 to sevoflurane, but none to halothane; details not given). 18955056
Björnsson E, Davidsdottir L. The long-term follow-up after idiosyncratic drug-induced liver injury with jaundice. J Hepatol 2009; 50: 511-7. (Among 685 patients with drug induced liver disease, 27 had evidence of chronic liver injury during an average of 10 years of following, including a 31 year old woman who had mild halothane hepatitis [bilirubin peak 4.5 mg/dL] and was subsequently found to have an inactive, compensated cirrhosis and died of suicide 11 years later). 19155082
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. Multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury including one due to halothane and one to isoflurane, but none to other anesthetic agents). 20949552
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol 2010; 70: 721-8. (Worldwide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children, no anesthetic agents ranked in the top 40 causes) .21039766
Habibollahi P, Mahboobi N, Esmaeili S, Safari S, Dabbagh A, Alavian SM. Halothane-induced hepatitis: A forgotten issue in developing countries: Halothane-induced hepatitis. Hepat Mon 2011; 11: 3-6. (Review of halothane induced liver injury and the risk factors that might be used to as contraindications in countries where it is still used). 22087107
Safari S, Motavaf M, Seyed Siamdoust SA, Alavian SM. Hepatotoxicity of halogenated inhalational anesthetics. Iran Red Crescent Med J 2014; 16: e20153. (Review of hepatotoxicity of the volatile halogenated anesthetics). 25593732
Lin J, Moore D, Hockey B, Di Lernia R, Gorelik A, Liew D, Nicoll A. Drug-induced hepatotoxicity: incidence of abnormal liver function tests consistent with volatile anaesthetic hepatitis in trauma patients. Liver Int 2014; 34: 576-82. (Retrospective analysis of records from 1556 patients admitted to a trauma unit during 2008 identified 47 cases of possible volatile anesthetic related liver injury, including 12 who developed ALT levels above 200 U/L of whom 11 had fever and 6 eosinophilia, but none were jaundiced or developed acute liver failure). 23944929
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases of which 5 [3%] were attributed to halothane and caused acute liver failure, while no other volatile anesthetic was listed). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 2 were attributed to isoflurane, 1 to sevoflurane, but none to halothane, enflurane or desflurane). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Halothane: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=halothane/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D)+AND+(%222009/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Halothane: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=halothane)